# Panitumumab

## OVERVIEW

### Introduction

Panitumumab is a human monoclonal antibody to the epidermal growth factor (EGF) receptor, which is used in the treatment of refractory metastatic colorectal cancer. Panitumumab has been linked to minor serum enzyme elevations during therapy, but has not been implicated in cases of clinically apparent liver injury.

### Background

Panitumumab (pan” i toom’ ue mab) is a human monoclonal IgG2 antibody to the epidermal growth factor receptor (EGFR, HER1), which is used to treat EGFR-expressing metastatic colorectal cancer. Panitumumab has been shown to induce objective responses in metastatic colorectal cancer and to improve progression free survival. Effects appear to be greater in patients with the wild type as opposed to mutant KRAS status. Panitumumab was approved for use in the United States in 2006 and was the second monoclonal antibody to EGFR approved for use in metastatic colorectal cancer, the other agent being cetuximab (a chimeric mouse-human monoclonal IgG1 antibody) which has a similar profile of efficacy and safety. Panitumumab is available in liquid solution of 100, 200 and 400 mg in single dose vials (20 mg/mL) under the brand name Vectibix. The recommended regimen is 6 mg/kg intravenously every 14 days until disease progression or unacceptable toxicity. Skin toxicity is the most common side effect, occurring in 90% of patients and being severe in 16% to 19%. Other side effects include fatigue, abdominal pain, nausea, anorexia, diarrhea, electrolyte disturbance, leukopenia and infections. Less common, but potentially severe side effects include infusion reactions, hypersensitivity reactions, severe skin toxicity, severe diarrhea and dehydration, pulmonary embolism and ocular toxicities.

### Hepatotoxicity

The rates of serum aminotransferase elevations during panitumumab therapy have not been reported in any detail from clinical trials, but nor has the absence of such elevations. In the FDA review of panitumumab, ALT elevations above 5 times the upper limit of normal (ULN) were reported to be 6% and not greater than with placebo (5%) and there were no early discontinuations because of liver test abnormalities or hepatic serious adverse events. If present, serum aminotransferase elevations must have been self-limited and resolved even with continuing cyclic therapy. No individual case reports of clinically apparent, acute liver injury with symptoms or jaundice attributed to panitumumab have been published and the product label does not discuss hepatotoxicity.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the transient enzyme elevations during monoclonal antibody therapies is generally unknown, but may relate to direct effects of the antibody reactivity to cell surface markers that may be over-expressed on cancer cells, but are also present in lower density on normal epithelial cells.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Panitumumab – Vectibix®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Panitumumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Panitumumab | 339177-26-3 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2020

Abbreviations: EGFR, epidermal growth factor receptor; TNF, tumor necrosis factor.

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the tumor necrosis factor [TNF] alpha antagonists").
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2006/125147s0000_MedR.pdf (FDA website on panitumumab with medical review for efficacy and safety).
Rowinsky EK, Schwartz GH, Gollob JA, Thompson JA, Vogelzang NJ, Figlin R, Bukowski R, et al. (2004). Safety, pharmacokinetics, and activity of ABX-EGF, a fully human anti-epidermal growth factor receptor monoclonal antibody in patients with metastatic renal cell cancer. J Clin Oncol. (Among 88 patients with resistant, metastatic renal cancer treated with one of 4 doses of panitumumab intravenously once weekly, there was scant evidence of benefit and side effects were common, 68-100% of patients developing an acneiform rash, but ALT elevations and hepatotoxicity were not mentioned).
Van Cutsem E, Peeters M, Siena S, Humblet Y, Hendlisz A, Neyns B, Canon JL, et al. (2007). Open-label phase III trial of panitumumab plus best supportive care compared with best supportive care alone in patients with chemotherapy-refractory metastatic colorectal cancer. J Clin Oncol. (Among 463 patients with metastatic, refractory colorectal cancer treated with panitumumab every two weeks or best supportive care, progression free survival was prolonged from a median of 7.3 to 8.0 weeks in the monoclonal antibody treated subjects, but overall survival was unchanged; side effects included skin toxicity in almost all patients; no mention of ALT elevations or hepatotoxicity).
(2007). Panitumumab (Vectibix) for metastatic colorectal cancer. Med Lett Drugs Ther.
Med Lett Drugs Ther 2007; 49(1262): 48; dosage error in article text. (Concise review of the efficacy and safety of panitumumab shortly after its approval for use in the US for metastatic colorectal cancer, mentions the frequency of skin related toxicities, but does not mention ALT elevations or hepatotoxicity).
Giusti RM, Shastri K, Pilaro AM, Fuchs C, Cordoba-Rodriguez R, Koti K, Rothmann M, et al. (2008). U.S. Food and Drug Administration approval: panitumumab for epidermal growth factor receptor-expressing metastatic colorectal carcinoma with progression following fluoropyrimidine-, oxaliplatin-, and irinotecan-containing chemotherapy regimens. Clin Cancer Res. (Analysis of efficacy and safety results that provided the basis for the FDA decision to approve panitumumab for use in metastatic colorectal cancer; combined safety analysis in 1467 patients mentions skin toxicity in 90% [severe in 16%], diarrhea in 21% [severe in 2%], infusion reactions in 4% [severe in 1%], pulmonary fibrosis in 1%; among 117 deaths in panitumumab treated patients, 1 was listed as due to hepatic failure, but no details given and rates of ALT elevations not mentioned).
Wu M, Rivkin A, Pham T. (2008). Panitumumab: human monoclonal antibody against epidermal growth factor receptors for the treatment of metastatic colorectal cancer. Clin Ther. (Review of efficacy and safety of panitumumab for metastatic colorectal cancer mentions side effects of skin toxicity, infusion reactions, electrolyte disturbances, pulmonary complications and nail and hair changes, but does not mention ALT elevations or hepatotoxicity).
Stephenson JJ, Gregory C, Burris H, Larson T, Verma U, Cohn A, Crawford J, et al. (2009). An open-label clinical trial evaluating safety and pharmacokinetics of two dosing schedules of panitumumab in patients with solid tumors. Clin Colorectal Cancer. (Among 86 patients with advanced solid tumors treated with 6 or 9 mg/kg of panitumumab every 2 weeks, all patients had at least one adverse event and therapy was stopped early in 27% of patients, the most frequent side effects being skin rash and gastrointestinal symptoms; no mention of hepatotoxicity).
Nie F, Shen J, Tong JL, Xu XT, Zhu MM, Ran ZH. (2009). Meta-analysis: the efficacy and safety of monoclonal antibody targeted to epidermal growth factor receptor in the treatment of patients with metastatic colorectal cancer. J Dig Dis. (Systematic review of efficacy and safety of monoclonal antibodies to EGFR in metastatic colorectal cancer summarized 7 randomized trials with 4186 patients using cetuximab or panitumumab, reported similar rates of response and adverse events with the two agents; no mention of ALT elevations or hepatotoxicity).
Fakih M, Vincent M. (2010). Adverse events associated with anti-EGFR therapies for the treatment of metastatic colorectal cancer. Curr Oncol. (Review of frequency, nature and management of adverse effects of monoclonal anti-EGFR [cetuximab and panitumumab] therapy of metastatic colorectal cancer including skin, nail, hair, ocular toxicities, hypomagnesemia, diarrhea, and infusion reactions, but no mention of hepatotoxicity).
Baumgaertner I, Ratziu V, Vaillant JC, Hannoun L, Poynard T, André T. (2010). Bull Cancer. (Review of the hepatotoxicity of agents used for metastatic colorectal cancer mentions that the anti-EGFR monoclonal antibodies have not been reported to cause liver injury).
Stremitzer S, Sebio A, Stintzing S, Lenz HJ. (2014). Panitumumab safety for treating colorectal cancer. Expert Opin Drug Saf. (Review of mechanism of action and safety of panitumumab therapy of metastatic colorectal cancer discusses skin toxicity, hypomagnesemia, diarrhea and infusion reactions [which are less with panitumumab than cetuximab], but not hepatotoxicity or ALT elevations).
Douillard JY, Siena S, Cassidy J, Tabernero J, Burkes R, Barugel M, Humblet Y, et al. (2014). Final results from PRIME: randomized phase 3 study of panitumumab with FOLFOX4 for first-line treatment of metastatic colorectal cancer. Ann Oncol. (Among 1183 patients with previously untreated metastatic colorectal cancer given panitumumab and FOLFOX4 or FOLFOX4 alone, severe side effects more frequent in the panitumumab exposed patients included skin toxicity [27% vs 2%], diarrhea, hypokalemia, hypomagnesemia, fatigue and mucositis; no mention of hepatotoxicity or ALT elevations).
Peeters M, Price TJ, Cervantes A, Sobrero AF, Ducreux M, Hotko Y, André T, et al. (2014). Final results from a randomized phase 3 study of FOLFIRI {+/-} panitumumab for second-line treatment of metastatic colorectal cancer. Ann Oncol. (Among 1186 patients with previously treated metastatic colorectal cancer given panitumumab and FOLFIRI or FOLFIRI alone, adverse events that were more frequent with panitumumab therapy included site toxicity, hypokalemia and hypomagnesemia; no mention of ALT elevations or hepatotoxicity).
Kim TW, Elme A, Kusic Z, Park JO, Udrea AA, Kim SY, Ahn JB, et al. (2016). A phase 3 trial evaluating panitumumab plus best supportive care vs best supportive care in chemorefractory wild-type KRAS or RAS metastatic colorectal cancer. Br J Cancer. (Among 677 patients with metastatic colorectal cancer treated with panitumumab or standard of care alone, overall survival is improved by the combination [10 vs 6.9 months], while adverse event rates were higher [97% vs 61%] particularly for rash [31% vs 1%], acneiform dermatitis [29% vs 0%], hypomagnesemia [28% vs 1%], itching [25% vs 2%]; but no mention of ALT elevations or hepatotoxicity).
Kamo H, Shinozaki E, Sugase T, Mizunuma N, Taniguchi S, Gotoh T, Chin K, et al. (2019). Leukocytoclastic vasculitis with purpura and renal failure induced by the anti-epidermal growth factor receptor antibody panitumumab: a case report. J Med Case Rep. (67 year old Japanese man with advanced colon cancer developed rash and renal dysfunction 2 days after a second infusion of panitumumab, liver tests not mentioned).
Hisaka T, Ishikawa H, Sakai H, Kawahara R, Goto Y, Nomura Y, Yasunaga M, et al. (2019). Sinusoidal obstruction syndrome and postoperative complications resulting from preoperative chemotherapy for colorectal cancer liver metastasis. Anticancer Res. (Among 90 patients with colorectal cancer and liver metastases treated with preoperative mFOLFOX6 with or without bevacizumab, panitumumab or cetuximab, liver histology at time of resection sinusoidal injury was seen in all groups, but was less severe in those who had received bevacizumab).

## OTHER REFERENCE LINKS

1 Recent References on Panitumumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Panitumumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Panitumumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Panitumumab)